# Codeine

## OVERVIEW

### Introduction

Codeine is one of the natural plant alkaloids found in extracts of opium and is commonly used to treat mild-to-moderate pain and cough. Codeine, like other opioids, has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Codeine (koe’ deen) is a natural alkaloid derived from resin extracts from the seeds of the opium poppy, Papaver somniferum. Codeine has opiate-like analgesic effects, but is much less potent than morphine. Codeine, however, is well absorbed orally and is less likely to cause serious respiratory depression than morphine. Codeine has been used in clinical medicine for more than a century and is currently approved for use in the United States as an oral analgesic for mild-to-moderate pain and, in low doses, as an antitussive for suppression of nonproductive cough. Codeine is available in multiple formulations including oral tablets of 15, 30 and 60 mg, as well as oral solutions and solutions for injection (subcutaneously, intramuscularly, intravenously) in varying concentrations. The typical adult, oral dose of codeine for analgesia is 15 to 60 mg every 4 to 6 hours. In addition, multiple commercial products combining codeine with acetaminophen for therapy of mild-to-moderate pain are available generically and under brand names such as Codrix and Codet. Side effects of codeine include sedation, respiratory depression, mental clouding, euphoria, agitation, constipation, abdominal bloating, nausea, vomiting and constipation. Codeine is a controlled substance and classified as a Schedule III drug, indicating that it has medical usefulness, but also a potential for physical and psychological dependency and abuse. Codeine is also available in low concentrations (~12 mg/tablet) in combination with antihistamines, antitussants or sympathomimetic agents for symptomatic therapy of upper respiratory infections and cough. These products are typically available over-the-counter without prescription.

### Hepatotoxicity

Despite wide use for many years, codeine has not been linked to serum enzyme elevations during therapy and there have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to its use.

Liklihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of codeine are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Codeine – Generic, Codrix®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Codeine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Codeine | 76-57-3 | C18-H21-N-O3 | Codeine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Codeine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Codeine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Codeine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Codeine)